# Amiodarone

## OVERVIEW

### Introduction

Amiodarone is a potent arrhythmia suppressing agent that has been clearly linked to several distinct forms of drug induced liver disease.

### Background

Amiodarone (a" mee oh' da rone) is an iodinated benzofuran derivative that is a structural analogue of thyroid hormone but is used as an arrhythmia suppressing agent. Amiodarone may interact with thyroid nuclear receptors, but its antiarrhythmic effects are believed to be mediated by its action in blocking membrane ion channels via perturbation of the lipid environment in the membrane bilayer. Amiodarone is highly lipophilic and is concentrated in many tissues and cells, including hepatocytes. It has a slow onset of action and a long but variable elimination half-life (up to 6 months) and, when given chronically, can accumulate in tissues including the liver. Amiodarone is highly effective in suppressing ventricular arrhythmias and in maintaining sinus rhythm in patients with atrial fibrillation. Amiodarone was first approved for use in the United States in 1985 and it is still widely used with approximately two million outpatient prescriptions written yearly. Approved indications are limited to recurrent, serious ventricular arrhythmias which have not responded to other available antiarrhythmics. In addition, amiodarone is frequently used off-label for suppression of atrial fibrillation and maintenance of normal sinus rhythm after cardioversion. Amiodarone is available in tablets of 200 and 400 mg in generic forms and under the brand names of Cordarone and Pacerone. It is also available in solution for intravenous administration. Amiodarone is typically given in high loading doses of 800 to 1600 mg daily, either intravenously or orally until the arrhythmia is controlled, and as maintenance oral doses for long term therapy of 200 to 600 mg daily. Liver toxicity appears to be more common with higher doses. Amiodarone has multiple adverse side effects including fatigue, tremor, involuntary movements, poor coordination, peripheral neuropathy, nausea, vomiting, constipation, anorexia, confusion, hallucinations, visual disturbances, corneal deposits, skin discoloration and rash, photosensitivity, bradycardia, and worsening of arrhythmias. Potentially severe adverse events which can be serious and occasionally fatal include pneumonitis, pulmonary fibrosis, optic neuropathy, blindness, thyroid dysfunction, Stevens-Johnson syndrome, toxic epidermal necrosis, hemolytic anemia, neurologic toxicity worsening arrhythmias, embryo-fetal toxicity, and liver injury.

### Hepatotoxicity

While liver injury from amiodarone is uncommon, it is not rare. Serum enzyme elevations are reported to occur in 15% to 50% of patients on long term therapy, but with lower doses (200 to 300 mg daily), ALT elevations are less common. Often these elevations resolve despite continuation of amiodarone, and liver biopsy may reveal minimal changes, or accumulation of granular material in macrophages without other evidence of injury. Patients taking amiodarone are recommended to have ALT and AST values taken at baseline and then every six months, and to discontinue therapy if levels are persistently greater than twice the upper limit of the normal range. The efficacy of this approach, even if followed, in preventing serious liver injury from amiodarone is unclear.

Clinically apparent liver disease arises in up to 1% of amiodarone-treated patients annually. The liver injury occurs more frequently with higher doses and prolonged therapy, and total cumulative dosage may be important as amiodarone can accumulate and can persist in liver tissue, even long after therapy is stopped. Typically, patients develop symptoms of fatigue, nausea and weight loss without jaundice and are found to have hepatomegaly and mild-to-moderate elevations in serum aminotransferase and alkaline phosphatase levels. Jaundice can occur but is mild; however, with severe injury, jaundice can progress and there may be prolongation of the prothrombin time and fall in serum albumin levels, and development of signs and symptoms of end stage liver disease with progressive weakness, weight loss, ascites, and hepatic encephalopathy (Cases 1 and 2). The injury resembles alcoholic liver disease clinically and histologically, although serum ALT and AST are usually elevated to a similar degree in amiodarone toxicity in contrast to alcoholic liver injury. Like in alcoholic liver disease, the ALT elevations are generally modest with normal or minimally elevated alkaline phosphatase levels. However, the pattern of enzyme elevations can vary from marked ALT elevations in a hepatocellular injury pattern, to minimal ALT increases with more prominent alkaline phosphatase elevations in a cholestatic pattern. The injury resolves slowly after stopping therapy and in some cases progresses for a period despite discontinuation. Liver biopsy shows variable findings; early there is micro- and macrovesicular fat, ballooning degeneration, and mild inflammation, whereas later there is moderate inflammation (sometimes granulomatous) and variable amounts of fibrosis and Mallory bodies but little steatosis. Electron microscopy reveals characteristic abnormal mitochondria and phospholipid laden lysosomes (seen on light microscopy as granular cells), but these changes can be observed even in the absence of significant liver injury. The liver is often bright on CT scan without contrast, due to accumulation of the iodinated drug and not necessarily indicating liver injury. Amiodarone and its derivatives can be detected in plasma and in hepatic tissue, and these levels may remain high for months if not years after stopping.

Amiodarone has also been associated with rare cases of Reye Syndrome, usually arising in a child on chronic amiodarone therapy who develops an acute viral syndrome suggesting influenza. Amiodarone, like aspirin, has been shown to interfere with mitochondrial function, which may be the basis for the acute injury resembling Reye syndrome in susceptible children.

Finally, amiodarone is capable of causing a distinctly different form of liver injury when it is given intravenously, particularly if given in high doses to elderly or frail patients (Cases 3 and 4). Serum ALT and AST can be markedly elevated (10 to 100 fold) within a day of the infusion, with minimal increases in alkaline phosphatase. Renal insufficiency can also occur. Usually, the liver injury reverses quickly with stopping the infusion, with ALT and AST falling into the normal range within days. In rare instances, jaundice and even acute liver failure have occurred shortly after initiating intravenous amiodarone therapy. Importantly, the mechanism of injury in this acute situation is probably different than in chronic exposure, and patients with acute hepatic injury following intravenous infusions of amiodarone can usually tolerate oral therapy without complications. However, reexposure to intravenous amiodarone is usually followed by reappearance of the acute injury.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of amiodarone hepatotoxicity appears to be direct damage to lipid bilayers and disturbance of lysosomal and/or mitochondrial function. Amiodarone appears to be potent inhibitor of phospholipase A accounting for the accumulation of lipid-rich material in lysosomes. The pattern of injury also suggests mitochondrial injury and dysfunction resulting in microvesicular fat and ballooning degeneration, which leads to fibrosis and Mallory body formation. The acute liver injury from intravenous amiodarone has been variously attributed to idiosyncratic toxicity, hypersensitivity and toxicity of the vehicle (polysorbate 80). Autopsy material from patients with acute hepatic injury after intravenous amiodarone shows centrolobular necrosis and collapse with minimal inflammation and no appreciable fat, changes that are suggestive of ischemic hepatitis. Because amiodarone is often used in patients with advanced heart disease, the cause of the acute liver injury may be hypotension caused by the infusion rather than a direct effect of the drug.

### Outcome and Management

The product label for amiodarone has a specific warning about hepatotoxicity that can be severe and even fatal. Monitoring for signs and symptoms of liver disease is recommended as well as periodic monitoring of serum aminotransferase levels with discontinuation if signs or symptoms of liver disease arise. The chronic injury that occurs with long term oral amiodarone therapy is typically prolonged and resolves slowly over months. Indeed, some patients are left with permanent injury, with findings of hepatomegaly and inactive cirrhosis. Oral amiodarone therapy should be discontinued if there is any clinical evidence of hepatic injury or symptoms (hepatomegaly, weakness, ascites, jaundice) or if serum aminotransferase activities are consistently elevated more than three times the upper limit of normal. In situations in which amiodarone is considered life sustaining, liver biopsy can guide whether the medication should be discontinued or not. Imaging can be helpful, but the finding of a bright liver is common with chronic therapy even in the absence of significant liver injury. Noninvasive markers of serious liver injury include persistent decreases in serum albumin levels, prolongation of INR, and decrease in platelet count. There are no specific therapies or antidotes for amiodarone toxicity.

Intravenous amiodarone should only be given with careful monitoring and repeat serum aminotransferase testing at least daily if not every 12 hours. The acute hepatic necrosis like injury from iv amiodarone is rapidly reversible if the infusion is stopped promptly and early. Treatment with N-acetylcysteine has been proposed as being beneficial, but is not of proven efficacy, and can have its own toxicities.

Drug Class: Antiarrhythmic Agents

See also: Dronedarone

## CASE REPORTS

### Case 1. Cirrhosis and end stage liver disease from long term therapy with amiodarone.(1)

A 62 year old man with chronic heart disease and a history of ventricular arrhythmias had been treated with amiodarone for almost 9 years, when he presented with progressive weakness, abdominal discomfort and jaundice. He had had several episodes of raised serum aminotransferase levels while on long term amiodarone, but had never been jaundiced. He had no risk factors for viral hepatitis and did not drink alcohol. His weight was normal with a body mass index of 23 kg/m^2^. He had multiple serious medication problems including coronary artery disease, hypertension, congestive heart failure, emphysema, pulmonary hypertension, hypercholesterolemia, mild renal insufficiency, migraine headaches, cholelithiasis, and ulcerative colitis for which he received multiple medications listed below. The dose of amiodarone had varied from 150 to 1000 mg daily, but averaged 400 mg daily for the previous several years. On presentation, his total serum bilirubin was 3.0 with direct 2.0 mg/dL, ALT 781 U/L, AST 734 U/L and alkaline phosphatase 119 U/L. The prothrombin time was initially normal but serum albumin was low at 2.9 g/dL. Tests for hepatitis A, B and C were negative; he had a high titer of antinuclear antibody (1:640) but no mitochondrial antibody. Ultrasound showed hepatosplenomegaly and a small amount of ascites. A liver biopsy showed micronodular cirrhosis with ballooning degeneration of hepatocytes and Mallory bodies, but little steatosis. Amiodarone was stopped and his aminotransferase levels fell rapidly. Nevertheless, he continued to deteriorate over the next month with bilirubin rising to 7.6 mg/dL, albumin falling to 2.2 g/dL and prothrombin time rising to 23.3 seconds. He developed progressive obtundation and died approximately 8 weeks after stopping amiodarone.

#### Key Points

Medication: | Amiodarone (averaging 400 mg daily)
Pattern: | Hepatocellular (R=13.1)
Severity: | 5+ (liver failure and death within 6 months of diagnosis)
Latency: | 9 years
Recovery: | Died of progressive hepatic insufficiency
Other medications: | Carvedilol, enalopril, spironolactone, pravastatin, esomeprazole, azathioprine, mesalamine, temazepam, iron, epoetin, thiamine, and multivitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | 49 | 80 | 0.5
1 year | | 67 | 114 | 0.6
5 years | | 40 | 80 | 1.0
6 years | | 48 | 96 | 1.2
7 years | | 123 | 111 | 0.8
8 years | | 42 | 89 | 1.3 | Protime normal
8.5 years | 0 | 781 | 119 | 3.0 | Albumin 2.9 g/dL
Amiodarone stopped
| 3 days | 477 | 111 | 2.8 | Liver biopsy
| 1 week | 281 | 110 | 2.1 | ANA 1:640
| 3 weeks | 100 | 167 | 5.6
| 4 weeks | 74 | 156 | 7.6 | Protime 23.3 sec
| 8 weeks | Died of hepatic failure
Normal Values | | <42 | <115 | <1.2

#### Comment

The history and clinical presentation were typical of chronic liver disease and cirrhosis due to long term amiodarone therapy. Also typical was the complexity of the underlying illness and multitude of other medical problems and drug exposures. During therapy the patient had mild elevations in serum aminotransferase levels with occasional periods of marked activity and mild jaundice, but these were self-limited and did not result in interruption of therapy. Indeed, a liver biopsy had been done at the time of a cholecystectomy after 6 years of amiodarone therapy that showed mild degrees of zone 3 (centrolobular) necrosis with minimal sinusoidal fibrosis, which was attributed to hypotension and congestive heart failure. There was no evidence of cirrhosis, inflammation or fat. Two years later he developed progressive weakness and jaundice and had marked elevations in ALT and AST. A liver biopsy showed changes that were typical of amiodarone hepatotoxicity: micronodular cirrhosis with ballooning degeneration of hepatocytes and Mallory bodies. Despite stopping amiodarone once the liver injury was identified, this patient suffered from progressive hepatic failure and died approximately 8 weeks later. Recovery from amiodarone hepatotoxicity is slow and patients such as this one may have a period of worsening after stopping therapy. While chronic alcoholism and obesity are mentioned as risk factors for developing amiodarone toxicity, many patients, such as in the case above, develop severe liver injury without either of these risk factors for fatty liver disease and cirrhosis. The periodic marked elevations in serum aminotransferase levels may represent periodic worsening of amiodarone hepatotoxicity or intermittent episodes of ischemic hepatic injury due to acute-on-chronic heart failure.

### Case 2. Cirrhosis with decompensation but ultimate recovery from long term therapy with amiodarone.(2)

A 73 year old man who was treated with amiodarone for atrial fibrillation developed fatigue and was found to have liver disease and cirrhosis. He had a long history of moderate social alcohol intake and obesity and was known to have minor elevations in serum aminotransferase levels, which were attributed to alcohol. During a period of stress, he developed atrial fibrillation without other signs of heart disease. After unsuccessful cardioversion, he was placed on amiodarone (300 mg daily). Within six months he noted the onset of worsening fatigue, weakness, weight loss, and increased need for sleep. On examination, he had an enlarged and firm liver with mild hepatic encephalopathy, asterixis, and fetor hepaticus. Serum aminotransferase levels were minimally abnormal and bilirubin remained less than 2.0 mg/dL. Serum ammonia levels were high. A liver biopsy was initially interpreted as showing alcoholic cirrhosis, but on review by expert hepatic pathologists the presence of granulomas, the frequency of Mallory bodies and the minimal fatty change suggested amiodarone hepatotoxicity. Both alcohol intake and amiodarone were stopped and he recovered. Mild episodes of hepatic encephalopathy were treated with lactulose, but three years later he was without symptoms, working full time and liver tests were normal.

#### Key Points

Medication: | Amiodarone
Pattern: | Hepatocellular (minimal elevations)
Severity: | 4+ (cirrhosis and hepatic decompensation)
Latency: | 6 months
Recovery: | Months
Other medications: | Multivitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
-3 months | | 56 | | 0.9
-1 month | | 34 | 102 | 0.6
Amiodarone started
2 months | | 96 | 98 | 0.9
6 months | | 67 | 115 | 1.7 | Liver biopsy: cirrhosis
Amiodarone stopped
| 1 week | 37 | 114 | 1.3 | Protime 14.5 sec
| 4 weeks | 39 | 102 | 1.7
| 8 weeks | 26 | 78 | 1.6 | Ammonia=96 µmol
| 12 weeks | 20 | 80 | 1.3
| 3 years | 15 | 81 | 1.3
Normal Values | | <42 | <115 | <1.2

#### Comment

The history and presentation were typical of liver injury from long term amiodarone therapy, but the history of moderate alcohol intake (2 to 5 drinks per day) and obesity made the diagnosis difficult. The quality of the inflammation, relative lack of steatosis and frequency of Mallory bodies on liver biopsy suggested amiodarone induced liver disease and led to its discontinuation. Also typical were the minimal abnormalities in laboratory tests (ALT, AST, and alkaline phosphatase). Laboratory tests improved rapidly but signs of underlying cirrhosis persisted as did mild hepatic encephalopathy. Amiodarone should probably be avoided in patients with heavy alcohol intake or with any evidence of underlying fatty liver disease.

### Case 3. Acute hepatocellular injury from high dose intravenous amiodarone therapy.(3)

A 48 year old woman with valvular heart disease and atrial fibrillation was treated with intravenous amiodarone and developed acute elevations in serum aminotransferase levels and mild jaundice that reversed rapidly. She had undergone both mitral and aortic valve replacement in the past and had chronic congestive heart failure that was worsened by the onset of rapid atrial fibrillation. After several days of monitoring she was given amiodarone using a bolus dose of 300 mg and then 900 mg daily. Discontinuation of intravenous amiodarone was followed by rapid fall of serum aminotransferase levels to pretreatment values.

#### Key Points

Medication: | Amiodarone (iv: total dose 2100 mg over two days)
Pattern: | Hepatocellular (R=13.1)
Severity: | 3+ (ALT elevations with jaundice and prolongation of hospitalization)
Latency: | 1 day
Recovery: | One to two weeks
Other medications: | Digoxin, verapamil, others not given

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
-3 days | | 45 | 145 | 2.0
-1 days | | 22 | 150 | 1.8
0 | | 28 | 185 | 1.8 | Amiodarone started
1 day | | 580 | 150 | 3.8
2 day | 0 | 1770 | 140 | 9.1 | Amiodarone stopped
| 1 days | 1450 | 140 | 8.5 | Viral markers negative
| 2 days | 740 | 160 | 5.9 | Autoantibodies negative
| 3 days | 700 | 156 | 4.7
| 5 days | 320 | 170 | 3.2
2 weeks | 10 days | 50 | 120 | 1.5
Normal Values | | <55 | <280 | <1.2

* Converted from µmol.

#### Comment

The patient experienced a marked rise in serum aminotransferase levels and appearance of jaundice within a day of starting intravenous amiodarone for atrial fibrillation. This patient probably had underlying chronic liver disease from chronic right heart failure as shown by the slight elevations in bilirubin and ALT levels before amiodarone therapy. Thus, amiodarone acute hepatic injury may occur predominantly in patients with an underlying degree of liver injury from heart failure and ischemia.

### Case 4. Acute hepatocellular injury from high dose intravenous amiodarone therapy.(4)

A 72 year old man with ischemic heart disease and multiple ventricular tachyarrhythmias developed acute hepatic injury within hours of receiving intravenous amiodarone. He had chronic congestive heart failure and suffered three sustained episodes of ventricular tachycardia and hypotension while in the hospital. He was given 1200 mg of intravenous amiodarone over a 24 hour period. Within 12 hours of starting amiodarone, ALT levels rose. Stopping therapy led to rapid improvements in blood test results, and treatment with oral amiodarone was tolerated without further injury.

#### Key Points

Medication: | Amiodarone (iv: total dose 1200 mg)
Pattern: | Hepatocellular (R=13.1)
Severity: | 1+ (ALT elevations without jaundice)
Latency: | 1 day
Recovery: | Several weeks
Other medications: | Not given

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | LDH (U/L) | Bilirubin (mg/dL) | Other
-1 day | | 69 | 167 | 1.2
0 | | 84 | 192 | 1.6
1 day | 0 | 4642 | 9262 | 4.2 | LDH 9262, protime 34 sec
2 days | 1 day | 7238 | 6204 | 3.7
4 days | 3 days | 2695 | 337 | 3.8
6 days | 5 days | 1360 | 196 | 2.1
2 weeks | 2 weeks | 289 | | 1.2 | Taking oral amiodarone
Normal Values | | <46 | <225 | <1.2

#### Comment

The patient experienced a marked rise in serum aminotransferase and lactic dehydrogenase levels within a day of starting intravenous amiodarone for ventricular tachyarrhythmias. The major difficulty in making the diagnosis of a drug induced liver injury from high dose amiodarone is that he also had multiple episodes of hypotension just before the abnormalities were identified, and the pattern of serum enzyme elevations with immediate worsening of prothrombin time and mild jaundice is also very typical of ischemic hepatitis. Most reported cases of acute hepatic injury from intravenous amiodarone have occurred in patients with the potential of ischemic liver injury (chronic heart failure and recent acute worsening due to tachyarrhythmias). Furthermore, the few liver biopsy specimens from such patients usually show centrolobular (zone 3) necrosis with minimal inflammation, suggestive of ischemic rather than an inflammatory injury. This patient later tolerated taking oral doses of amiodarone [600 mg daily] without recurrence of liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amiodarone – Generic, Cordarone®

DRUG CLASS

Antiarrhythmic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=amiodarone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Amiodarone | 1951-25-3 | C25-H29-12-N-O3

## CITED REFERENCES

1 Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. 18955056
2 A case from the National Institutes of Health Clinical Center
3 A case 1, from: Pye E, Northcote RJ, Cobbe SM. Acute hepatitis after parenteral amiodarone administration. Br Heart J 1988; 59: 690-1.3395527
4 Rhodes A, Eastwood JB, Smith SA. Early acute hepatitis with parenteral amiodarone: a toxic effect of the vehicle? Gut 1993; 34: 565-6 8491409

## ANNOTATED BIBLIOGRAPHY

References updated: 06 February 2026

Abbreviations: iv, intravenous; ULN, upper limit of normal.

Zimmerman HJ. Amiodarone. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 648-52. (Expert review of hepatotoxicity published in 1999; patterns of liver injury associated with oral amiodarone include frequent minor serum enzyme elevations [14% to 83%] and less commonly chronic liver disease resembling alcoholic hepatitis and cirrhosis, acute hepatitis with jaundice, phospholipidosis, Reye syndrome and cholestasis; amiodarone also interferes with the metabolism of other drugs).
De Marzio DH, Navarro VJ. Amiodarone. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 520-1. (Review of hepatotoxicity of amiodarone; mentions several patterns of injury including acute injury during intravenous [iv] use and both acute and chronic liver injury associated with long-term oral use).
Knollman BC, Roden DM. Antiarrhythmic drugs. In Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 547-572. (Textbook of pharmacology and therapeutics).
Waxman HL, Groh WC, Marchlinski FE, Buxton AE, Sadowski LM, Horowitz LN, Josephson ME, Kastor JA. Amiodarone for control of sustained ventricular tachyarrhythmia: clinical and electrophysiologic effects in 51 patients. Am J Cardiol 1982; 50: 1066-74. (Experience with oral amiodarone [600-800 mg/day] in 51 patients with arrhythmias; 55% had at least one adverse reaction, 22% required stopping, 41% had ALT elevations [1.5-3 times upper limit of normal: ULN] and 2 [4%] developed hepatitis, one progressing to cirrhosis: first prominent description of hepatic side effects of amiodarone). 6291368
Fogoros RN, Anderson KP, Winkle RA, Swerdlow CD, Mason JW. Amiodarone: clinical efficacy and toxicity in 96 patients with recurrent, drug-refractory arrhythmias. Circulation 1983; 68: 88-94. (96 patients treated with oral amiodarone [600-1200 mg/day] for up to 27 months, 73% developed side effects, 15% required discontinuation; one had ALT elevations of 3000-5000 U/L during first month, levels rapidly falling to normal upon stopping). 6851057
Harris L, McKenna WJ, Rowland E, Holt DW, Storey GC, Krikler DM. Side effects of long-term amiodarone therapy. Circulation 1983; 67: 45-51. (Retrospective analysis of side effects in 140 patients taking oral amiodarone for 1-5 years, average doses from 100-400 mg/day, 6% had thyroid and 1% pulmonary toxicity: 15% had ALT increases of 1.5 to 4 times ULN but none had overt liver injury; correlation found between amiodarone concentration in liver and increased ALT levels). 6291807
McGovern B, Garan H, Kelly E, Ruskin JN. Adverse reactions during treatment with amiodarone hydrochloride. Br Med J (Clin Res Ed). 1983; 287: 175-80. (Side effects among 80 patients treated with amiodarone for up to 51 months; 88% had an adverse reaction, 18% required stopping, 40% had ALT elevations; one had hepatitis). 6409240
Lim PK, Trewby PN, Storey GC, Hole DW. Neuropathy and fatal hepatitis in a patient receiving amiodarone. Br Med J (Clin Res Ed) 1984; 288: 1638-9. (68 year old man presented with cirrhosis after 19 months of oral amiodarone therapy [400 mg/day]; stopping drug led to decrease in ALT and alkaline phosphatase levels, but clinical progression with ascites followed by death 5 months later). 6326931
Poucell S, Ireton J, Valencia-Mayoral P, Downar E, Larratt L, Patterson J, Blendis L, Phillips MJ. Amiodarone-associated phospholipidosis and fibrosis of the liver. Light, immunohistochemical, and electron microscopic studies. Gastroenterology 1984; 86: 926-36. (Two women and one man, ages 61 to 64 years, presented with fatigue or hepatomegaly after 1-2 years of oral amiodarone therapy [bilirubin 0.6, 0.5 and 1.3 mg/dL, ALT 80, 82 and 680 U/L, Alk P 80, 98, and 188 U/L, albumin 0.8-3.7 g/dL]; liver histology showed Mallory bodies, ballooning, micro- and macro-steatosis, fibrosis and inflammation, 2 had cirrhosis; electron microscopy showed lysosomal inclusions and pleomorphic mitochondria). 6706074
Simon JB, Manley PN, Brien JF, Armstrong PW. Amiodarone hepatotoxicity simulating alcoholic liver disease. N Engl J Med 1984; 311: 167-72. (Clinical and histological description of amiodarone hepatotoxicity in a 30 year old man treated with oral amiodarone [400 mg/day] for 6 months, injury persisting for over a year after stopping). 6738602
Goldman IS, Winkler ML, Raper SE, Barker ME, Keung E, Goldberg HI, Boyer TD. Increased hepatic density and phospholipidosis due to amiodarone. Am J Roentgenol 1985; 144: 541-6. (Increased density of liver on computerized tomography [CT] found in all 7 patients on oral amiodarone for 10-60 months, liver biopsies were normal, but electron microscopy showed phospholipidosis). 3871563
Jones WP, Shin MS, Stanley RJ, Duncan-Myers J. Dense liver in a 72-year-old woman with congestive heart failure. Invest Radiol 1985; 20: 911-5. (70 year old woman developed pulmonary toxicity after a 1 year course of amiodarone with CT showing dense liver, normal liver tests and no attenuation in the spleen). 4077446
Tordjman K, Katz I, Bursztyn M, Rosenthal T. Amiodarone and the liver. Ann Intern Med 1985; 102: 411-2. (76 year old woman developed cirrhosis after 2.5 years of oral amiodarone therapy [200 mg/day] [bilirubin normal, AST 225 U/L, Alk P 317 U/L, albumin 2.9 g/dL], with encephalopathy and death from liver failure 2 weeks later). 3970484
Varma RR, Troup PJ, Komorowski RA, Sarna T. Clinical and morphologic effects of amiodarone on the liver. Gastroenterology 1985; 88: 1091-3. (2 men, ages 24 and 58 years, on oral amiodarone for several years had fluctuating but mild serum ALT elevations and normal liver histology, but phospholipidosis by electron microscopy). 3972228
Yagupsky P, Gazala E, Sofer S, Maor E, Abarbanel J. Fatal hepatic failure and encephalopathy associated with amiodarone therapy. J Pediatr 1985; 107: 967-70. (8 year old girl developed Reyes-like syndrome 2 months after starting amiodarone [bilirubin 1.5 mg/dL, ALT 5610 U/L, high ammonia], dying within 2 days of admission; biopsy showed ballooning degeneration without fat or Mallory bodies). 4067758
Dake MD, Madison JM, Montgomery CK, Shellito JD, Hinchcliffe WA, Winkler ML, Bainton DF. Electron microscopic demonstration of lysosomal inclusion bodies in lung, liver, lymph nodes, and blood leukocytes of patients with amiodarone pulmonary toxicity. Am J Med 1985; 78: 506-12. (Two cases of pulmonary toxicity from amiodarone after 15 and 22 months of 500-600 mg daily; electron microscopy showed lysosomal inclusions in multiple tissues including lymph nodes, neutrophils, lymphocytes and with liver showing normal light microscopic findings). 2983550
Adams PC, Bennett MK, Holt DW. Hepatic effects of amiodarone. Br J Clin Pract Suppl 1986; 44: 81-95. (Review of hepatic distribution of amiodarone, CT attenuation and liver effects in 10 patients). 3089267
Babany G, Mallat A, Zafrani ES, Saint-Marc Girardin MF, Carcone B, Dhumeaux D. Chronic liver disease after low daily doses of amiodarone. Report of three cases. J Hepatol 1986; 3: 228-32. (3 women, ages 56-83 years, developed hepatomegaly with mild or no ALT [60-139 U/L] and alkaline phosphatase [73-139 U/L] elevations and no jaundice after 3-5 years of amiodarone therapy, with slow resolution over 6-10 months; biopsies showed fat, Mallory bodies, inflammation and fibrosis). 3794303
Lupon-Roses J, Simo-Canonge R, Lu-Cortez L, Permanyer-Miralda G, Allende-Monclus H. Probable early acute hepatitis with parenteral amiodarone. Clin Cardiol 1986; 9: 223-5. (77 year old man with congestive heart failure developed mild jaundice after 3 days of iv amiodarone [bilirubin 6.3 mg/dL, ALT 1571 U/L], resolving rapidly upon stopping; liver biopsy showing centrolobular necrosis). 3708949
Rigas B, Rosenfeld LE, Barwick KW, Enriquez R, Helzberg J, Batsford WP, Josephson ME, Riely CA. Amiodarone hepatotoxicity. A clinicopathologic study of five patients. Ann Intern Med 1986; 104: 348-51. (5 cases of amiodarone hepatotoxicity with variability in presentation, all were symptomatic, but none were icteric [ALT 64-1320 U/L, Alk P 70-336 U/L] arising 2-18 months after starting oral therapy; liver histology given but little information in follow up). 3946978
Rinder HM, Love JC, Wexler R. Amiodarone hepatotoxicity. N Engl J Med 1986; 314: 318-9.3941726
(68 year old man developed ascites 22 months after starting oral amiodarone [initial bilirubin normal, ALT 180 U/L, Alk P 422 U/L] who subsequently developed progressive encephalopathy and died) .
Rumessen JJ. Hepatotoxicity of amiodarone. Acta Med Scand 1986; 219: 235-9. (72 year old man developed jaundice 7 weeks after starting oral amiodarone [400 mg/day] [bilirubin 2.4 mg/dL, ALT 1.5 times ULN, Alk P 805 U/L], with exposure to several other potential hepatotoxins: ajmaline, methyldopa and chlorpromazine, resolving within a few weeks of stopping). 3962737
Mason JW. Amiodarone. N Engl J Med 1987; 316: 455-66. (Thorough review of pharmacology, efficacy and safety of amiodarone including adverse reactions; hepatitis occurred in 1-4% of patients treated in large case series). 3543680
Shepherd NA, Dawson AM, Crocker PR, Levison DA. Granular cells as a marker of early amiodarone hepatotoxicity: a pathological and analytical study. J Clin Pathol 1987; 40: 418-23. (1 man and 1 woman, both 64 years old, developed symptomatic hepatomegaly 8 months and 7 years after starting amiodarone, one resolved and one developed liver failure; biopsies showed cells with lysosomal whorls and granular cytoplasm which harbored amiodarone). 3584485
Gilinsky NH, Briscoe GW, Kuo CS. Fatal amiodarone hepatoxicity. Am J Gastroenterol 1988; 83: 161-3. (74 year old man developed ascites 28 months after starting oral amiodarone [bilirubin 7.8 mg/dL, ALT 110 U/L, Alk P 275 U/L, albumin 1.6 g/dL], with subsequent progression and death despite stopping therapy). 3341340
Giordano G, Franciosini MF, Zuanetti G, Latini R. [Digitalis intoxication in the presence of amiodarone-induced acute hepatitis] G Ital Cardiol 1988; 18: 862-4. Italian. PMID: 3246320
Guigui B, Perrot S, Berry JP, Fleury-Feith J, Martin N, Metreau JM, Dhumeaux D, Zafrani ES. Amiodarone-induced hepatic phospholipidosis: a morphological alteration independent of pseudo-alcoholic liver disease. Hepatology 1988; 8: 1063-8. (Biopsies from 13 patients on oral amiodarone for 4 months to 15 years; all cases showed iodine rich intralysosomal myelin figures, various degrees of injury from steatohepatitis to normal; follow up of Babany et al.). 3417226
Kowey PR, Friehling TD, Marinchak RA, Sulpizi AM, Stohler JL. Safety and efficacy of amiodarone. The low-dose perspective. Chest 1988; 93: 54-9. (Among 68 patients treated with oral amiodarone for 4 to 58 months [200-600 mg/day], ~10% had ALT elevations, but none developed clinically apparent liver disease). 3335168
Morse RM, Valenzuela GA, Greenwald TP, Eulie PJ, Wesley RC, McCallum RW. Amiodarone-induced liver toxicity. Ann Intern Med 1988; 109: 838-40. (67 year old woman developed jaundice 7 months after starting oral amiodarone [400 to 200 mg/day] [bilirubin 2.4 rising to 16.4 mg/dL, ALT 41 U/L, Alk P 508 U/L], resolving slowly once drug was stopped). 3190031
Pye M, Northcote RJ, Cobbe SM. Acute hepatitis after parenteral amiodarone administration. Br Heart J 1988; 59: 690-1. (Two cases of acute ALT elevations [1860 and 2400 U/L] with jaundice [peak bilirubin 9.1 and 3.5 mg/dL] after 2 days of iv amiodarone, resolving rapidly: Case 3). 3395527
Jones DB, Mullick FG, Hoofnagle JH, Baranski B. Reye's syndrome-like illness in a patient receiving amiodarone. Am J Gastroenterol 1988; 83: 967-9. (16 year old boy taking amiodarone developed Reye syndrome after influenza-like illness, biopsy showing microvesicular fat, rapid recovery despite continuing amiodarone). 3414648
Bach N, Schultz BL, Cohen LB, Squire A, Gordon R, Thung SN, Schaffner F. Amiodarone hepatotoxicity: progression from steatosis to cirrhosis. Mt Sinai J Med 1989; 56: 293-6. (75 year old woman developed fever and hepatomegaly 7 months after starting amiodarone therapy [800 mg/day] [bilirubin not given, AST 140 U/L, Alk P 850 U/L]; despite reduction in dose, she developed cirrhosis over the next 20 months: initial biopsy showed micro- and macrovesicular fat and ballooning; later biopsy showed cirrhosis, inflammation, granular cells and Mallory bodies but no steatosis). 2797021
Flaharty KK, Chase SL, Yaghsezian HM, Rubin R. Hepatotoxicity associated with amiodarone therapy. Pharmacotherapy 1989; 9: 39-44. (77 year old man presented with cirrhosis after 1 year of 400-600 mg of oral amiodarone daily [bilirubin 2.7 mg/dL, ALT 124 U/L, Alk P 459 U/L, albumin 3.0 g/dL], with progression despite stopping drug and death 21 days later). 2646621
Kerin NZ, Aragon E, Faitel K, Frumin H, Rubenfire M. Long-term efficacy and toxicity of high- and low-dose amiodarone regimens. J Clin Pharmacol 1989; 29: 418-23. (Review of low vs high dose long term efficacy and safety of amiodarone; hepatitis said to occur in 1.6% of patients). 2661600
Lewis JH, Ranard RC, Caruso A, Jackson LK, Mullick F, Ishak KG, Seeff LB, Zimmerman HJ. Amiodarone hepatotoxicity: prevalence and clinicopathologic correlations among 104 patients. Hepatology 1989; 9: 679-85. (Analysis of 104 patients taking amiodarone and followed prospectively, 25% developed ALT elevations [>2 times ULN] after 1-28 months, but only 3 developed clinically apparent liver injury: symptoms and ALT abnormalities resolved in 2 to 8 weeks; in 9 autopsies, 5 had liver abnormalities). 2785079
Robinson K, Mulrow JP, Rowland E, McKenna WJ. Long-term effects of amiodarone on hepatic function. Am J Cardiol 1989; 64: 95-6. (Brief summary of experience using oral amiodarone in 426 patients followed for 2 months to 13 years; 10% developed liver test abnormalities, but were largely mild and self-limiting, none resulting in clinical hepatitis or cirrhosis). 2741820
Roche JF, Netter P, Gay G. [Amiodarone-induced hepatitis: biological, histological diagnosis, development and role of associated factors. Review of the literature. Report of 2 cases] Rev Med Interne 1989; 10: 497-501. French. PMID: 2488499
Stevenson RN, Nayani TH, Davies JR. Acute hepatic dysfunction following parenteral amiodarone administration. Postgrad Med J 1989; 65: 707-8. (59 year old man developed worsening jaundice during iv followed by oral amiodarone therapy [bilirubin peak 20.7 mg/dL, ALT 440 U/L, Alk P 255 U/L], resolving with few weeks of stopping). 2608608
Fromenty B, Fisch C, Labbe G, Defott C, Deschamps D, Berson A, Letteron P, Pessayre D. Amiodarone inhibits the mitochondrial beta-oxidation of fatty acids and produces microvesicular steatosis of the liver in mice. J Pharmacol Exp Ther 1990; 255: 1371-6. (In mice, amiodarone decreases beta oxidation of palmitic acid in mitochondrial preparations and in vivo, with increase in triglycerides and microvesicular fat 24 hours after intraperitoneal administration of 600 mg/kg). 2124623
Lwakatare JM, Morris-Jones S, Knight EJ. Fatal fulminating liver failure possibly related to amiodarone treatment. Br J Hosp Med 1990; 44: 60-1. (64 year old woman developed acute liver failure 3 weeks after starting amiodarone [bilirubin 25.6 mg/dL, ALT 2350 U/L, Alk P 444 U/L], dying within 3 days of admission, autopsy showing extensive centrolobular necrosis without inflammation). 2397338
Lewis JH, Mullick F, Ishak KG, Ranard RC, Ragsdale B, Perse RM, Rusnock EJ, et al. Histopathologic analysis of suspected amiodarone hepatotoxicity. Hum Pathol 1990; 21: 59-67. (Summary of 19 cases of amiodarone hepatotoxicity from files of Armed Forces Institute of Pathology and review of literature: mean age 62 years [range 8 to 83 years], mostly men, mean dose 400 mg/day [200-800], duration of therapy 0.5-3.6 years; patients usually present with mild or no jaundice, hepatomegaly, mild ALT elevations and AST:ALT ratio <1.0, histology shows micro- and macro-vesicular fat, Mallory bodies, fibrosis, foam cells, ductular proliferation, lipogranulomas, and inflammation). 2403975
Pollak PT, Sharma AD, Carruthers SG. Relation of amiodarone hepatic and pulmonary toxicity to serum drug concentrations and superoxide dismutase activity. Am J Cardiol 1990; 65: 1185-91. (Prospective study of 30 patients treated with amiodarone for 12 months, 5 had ALT elevations, which were associated with higher doses and levels in serum and possibly drug accumulation). 2337027
Simon JP, Zannad F, Trechot P, Thisse JY, Houplon M, Aliot E. Acute hepatitis after a loading dose of intravenous amiodarone. Cardiovasc Drugs Ther 1990; 4: 1467-8. (59 year old man developed marked elevations in ALT [peak 3270 U/L] within a day of starting iv amiodarone with mild jaundice [peak bilirubin 2.4 mg/dL], rapid resolution [2 weeks] and recurrence on reexposure). 2081138
Benbassat C, Shahar A. [Acute fulminant hepatic failure after short-term amiodarone] Harefuah 1991; 121: 378-80. Hebrew. PMID: 1752554
Kalantzis N, Gabriel P, Mouzas J, Tiniakos D, Tsigas D, Tiniakos G. Acute amiodarone-induced hepatitis. Hepatogastroenterology 1991; 38: 71-4. (2 cases of severe ALT elevations [20360 U/L and 570 U/L] and jaundice [bilirubin 6.8 and 5.6 mg/dL] within 1 day of iv amiodarone, followed by acute liver and renal failure, and death: autopsies showed confluent necrosis, compatible with shock liver). 2026392
Morelli S, Guido V, De Marzio P, Aguglia F, Balsano F. Early hepatitis during intravenous amiodarone administration. Cardiology 1991; 78: 291-4. (Two cases of prompt increases in ALT [251 and 128 U/L], Alk P [505 and 482 U/L] and bilirubin levels [3.4 and 3.3 mg/dL] within 2-3 days of starting iv amiodarone, resolving in one week despite use of oral formulations of the drug). 1868505
Fornaciari G, Monducci I, Barone A, Bassi C, Beltrami M, Tomasi C. Amiodarone-induced acute hepatitis: case report. J Clin Gastroenterol 1992; 15: 271-3. (52 year old woman developed confusion and jaundice [bilirubin 3.5 mg/dL, ALT 2500 U/L], 36 hours after an amiodarone infusion and cardiac arrest, which resolved rapidly with stopping amiodarone). 1479182
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports in Denmark from 1978 to 1987; 10 of the 1188 reported cases [none were fatal] were attributed to amiodarone). 1506809
Harrison RF, Elias E. Amiodarone-associated cirrhosis with hepatic and lymph node granulomas. Histopathology 1993; 22: 80-2. (57 year old man developed signs of cirrhosis after 4.5 years of oral amiodarone therapy [400 mg/day] and underwent liver transplant: graft showed micronodular cirrhosis, Mallory bodies, granular cells, and granulomas surrounding ballooned cells; granulomas were present in lymph nodes as well). 8436346
Rhodes A, Eastwood JB, Smith SA. Early acute hepatitis with parenteral amiodarone: a toxic effect of the vehicle? Gut 1993; 34: 565-6. (72 year old man developed elevations in ALT [peak 4642 U/L] and LDH [peak 9262 U/L] within 2 days of iv amiodarone but tolerated oral drug later; authors suggested that the vehicle [polysorbate] was the cause: later considered unlikely: Case 4). 8491409
Macarri G, Feliciangeli G, Berdini V, Jezequel AM, Benedetti A. Canalicular cholestasis due to amiodarone toxicity. A definite diagnosis obtained by electron microscopy. Ital J Gastroenterol 1995; 27: 436-8.8775470
Rene JM, Buenestado J, Pais B, Pinol MC. [Cirrhosis caused by amiodarone] Rev Esp Enferm Dig 1995; 87: 399-402. Spanish. PMID: 7626301
Richer M, Robert S. Fatal hepatotoxicity following oral administration of amiodarone. Ann Pharmacother 1995; 29: 582-6. (64 year old man presented with cirrhosis 14 months after starting oral amiodarone [400-600 mg/day] [bilirubin 0.7 mg/dL, ALT 112 U/L, Alk P 176 U/L, INR 2.4] and despite stopping had subsequent progression to end stage liver disease and death 10 weeks later). 7663029
Snir Y, Pick N, Riesenberg K, Yanai-Inbar I, Zirkin H, Schlaeffer F. Fatal hepatic failure due to prolonged amiodarone treatment. J Clin Gastroenterol 1995; 20: 265-6. (62 year old woman developed weakness and jaundice one year after starting oral amiodarone [bilirubin 5.4 mg/dL, ALT 131 U/L, Alk P 329 U/L] and died of end stage liver disease 3 weeks after stopping: postmortem showed cirrhosis). 7797846
Tosetti C, Ongari M, Evangelisti A, Lolli R, Napoli A. [Acute hepatotoxicity from amiodarone] Minerva Med 1995; 86: 387-90. Italian. PMID: 7501229
Paniagua Clusells J, Arcusa Gavalda R, Goma Masip F, Pons Masanes S, Soler Masana JM. [Acute hepatitis caused by intravenous amiodarone.] Rev Esp Cardiol 1996; 49: 384-5. Spanish. PMID: 8744394
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; amiodarone accounted for 14 cases [1.5%, ranking 16th]). 8816722
Effect of prophylactic amiodarone on mortality after acute myocardial infarction and in congestive heart failure: metaanalysis of individual data from 6500 patients in randomised trials. Amiodarone Trials Meta-Analysis Investigators. Lancet 1997; 350: 1417-24. (Meta analysis using individual data from 13 trials of amiodarone in 6553 patients showed reduction in cardiac mortality of 13%; liver dysfunction more common with amiodarone than placebo [1% vs 0.4%], but no description of abnormalities). 9371164
James PR, Hardman SM. Acute hepatitis complicating parenteral amiodarone does not preclude subsequent oral therapy. Heart 1997; 77: 583-4. (50 year old man had acute ALT [peak 8220 U/L day 2] and bilirubin elevations [peak 3.0 mg/dL, day 4] after a day of iv amiodarone therapy, but later tolerated long term low dose oral drug without injury). 9227310
Josephson SA, Kessel ER. Amiodarone hepatotoxicity. Dig Dis 1997; 15: 312. (69 year old man developed pain and hepatomegaly after 18 months of amiodarone, biopsy showed toxic hepatitis and lamellar whorls in damaged lysosomes). 9359019
Pierce DR, Skaehill, PA. Case of fatal amiodarone hepatotoxicity. Hosp Pharm 1997; 32: 1133-5. Not in PubMed
Tagliamonte E, Cice G, Ducceschi V, Mayer MS, Iacono A. [Acute hepatitis following amiodarone administration] Minerva Cardioangiol 1997; 45: 451-6. Italian. PMID: 9446068
Vorperian VR, Havighurst TC, Miller S, January CT. Adverse effects of low dose amiodarone: a meta-analysis. J Am Coll Cardiol 1997; 30: 791-8. (Meta analysis of 4 controlled trials of amiodarone [n=738] vs placebo [n=727] found no differences in rates of ALT elevations >2-3 fold [1.2% vs 0.8%]). 9283542
Breuer HW, Bossek W, Haferland C, Schmidt M, Neumann H, Gruszka J. Amiodarone-induced severe hepatitis mediated by immunological mechanisms. Int J Clin Pharmacol Ther 1998; 36: 350-2. (64 year old developed ALT elevations [3780 U/L] and mild jaundice [bilirubin 1.8 mg/dL] 2 days after starting iv amiodarone, with resolution within 3 weeks of stopping). 9660045
Chang CC, Petrelli M, Tomashefski JF Jr, McCullough AJ. Severe intrahepatic cholestasis caused by amiodarone toxicity after withdrawal of the drug: a case report and review of the literature. Arch Pathol Lab Med 1999; 123: 251-6. (84 year old woman developed cirrhosis after 5 years of amiodarone therapy [400 mg/day] [bilirubin normal, ALT 154 U/L, Alk P 316 U/L]; despite stopping drug, patient developed liver decompensation, worsening jaundice and died 4 months later). 10086516
Iliopoulou A, Giannakopoulos G, Mayrikakis M, Zafiris E, Stamatelopoulos S. Reversible fulminant hepatitis following intravenous amiodarone loading. Amiodarone hepatotoxicity. Int J Clin Pharmacol Ther 1999; 37: 312-3. (69 year old man developed marked ALT elevations [50 times ULN] and jaundice within 1 day of starting iv amiodarone with full recovery within 2 weeks of stopping). 10395125
Latorre G, Lucas I, Herrero JI, Sangro B, Quiroga J, Sola JJ, Díaz L, Prieto J. [Severe hepatotoxicity caused by amiodarone: description of a case] Rev Med Univ Navarra 1999; 43: 86-91. Spanish. PMID: 11256009
Lopez-Gomez D, Nicolas J, Frigola JM, Manito N, Esplugas E. [The use of oral amiodarone as a chronic treatment in a patient with prior fulminant hepatitis due to intravenous amiodarone] Rev Esp Cardiol 1999; 52: 201-3. Spanish. PMID: 10193175
Jain D, Bowlus CL, Anderson JM, Robert ME. Granular cells as a marker of early amiodarone hepatotoxicity. J Clin Gastroenterol 2000; 31: 241-3. (40 year old man developed nausea 6 weeks after starting amiodarone [bilirubin 0.8 mg/dL, ALT 2250 U/L, Alk P 81 U/L], resolving rapidly with stopping and with mild ALT elevations on restarting; liver biopsy showing near normal histology except for granular cells suspected to be phospholipid containing macrophages). 11034006
Jmelnitzky AC, Guidi M, Bologna A, Viola M, Soccini C, Barbero R, Belloni P, Apraiz M. [Clinic-epidemiological significance of drug hepatotoxicity in liver disease consultation] Acta Gastroenterol Latinoam 2000; 30: 77-84. Spanish. PMID: 10925723
Luengo O, Montero J, Alegre J, Fernandez Sevilla T. [Toxic hepatitis caused by intravenous amiodarone] Med Clin (Barc). 2000; 115: 798-9. Spanish. PMID: 11171458
James PR, Barrera Groba C. Intravenous amiodarone in intensive care: time for a reappraisal? Intensive Care Med 2001; 27: 1433. (Letter stressing the abrupt ALT elevations after intravenous amiodarone therapy that may be due to the polysorbate carrier). 11511965
Agozzino F, Picca M, Pelosi G. Acute hepatitis complicating intravenous amiodarone treatment. Ital Heart J 2002; 3: 686-8. (83 year old man developed marked ALT elevations 24 hours after iv amiodarone [bilirubin 2.83 mg/dL, ALT 7440 U/L, INR 3.8, creatinine 2.3 mg/dL], resolving within 2 weeks). 12506529
Giannattasio F, Salvio A, Varriale M, Picciotto FP, Di Costanzo GG, Visconti M. Three cases of severe acute hepatitis after parenteral administration of amiodarone: the active ingredient is not the only agent responsible for hepatotoxicity. Ann Ital Med Int 2002; 17: 180-4.12402666
Gonzalez Galilea A, Garcia Sanchez MV, la Mata Garcia M, Mino Fugarolas G. [Early-onset acute toxic hepatitis induced by intravenous amiodarone administration] Gastroenterol Hepatol 2002; 25: 392-4. Spanish. PMID: 12069701
Gregory SA, Webster JB, Chapman GD. Acute hepatitis induced by parenteral amiodarone. Am J Med 2002; 113: 254-5. (74 year old woman developed marked ALT elevations [1099 U/L] within few days of starting daily infusions of amiodarone, and levels subsequently fell to normal despite use of oral drug). 12208392
Burri S, Hug MI, Bauersfeld U. Efficacy and safety of intravenous amiodarone for incessant tachycardias in infants. Eur J Pediatr 2003; 162: 880-4. (Prospective study of 23 infants given iv amiodarone; one child developed marked liver enzyme elevations, but no details were given). 14508682
MacFadyen RJ, Palmer TJ, Hisamuddin K. Rapidly fatal acute amiodarone hepatitis occurring in the context of multiple organ failure. Int J Cardiol 2003; 91: 245-7. (64 year old man developed severe ALT elevations and multiorgan failure soon after starting iv amiodarone for atrial fibrillation and heart failure; autopsy showed centrozonal necrosis). 14559139
Olsson R. Acute hepatitis after parenteral amiodarone. Ital Heart J 2003; 4: 355-6; Author reply 356-7.12848097
Singhal A, Ghosh P, Khan SA. Low Dose amiodarone causing pseudo-alcoholic cirrhosis. Age Ageing 2003; 32: 224-5. (79 year old man developed ascites and cirrhosis after 33 months of oral amiodarone therapy [200 mg/day] [bilirubin 0.8 mg/dL, ALT 67 U/L, Alk P 216 U/L], with relentless progression to hepatic failure and death 3 months after stopping amiodarone). 12615569
Stravitz RT, Sanyal AJ. Drug-induced steatohepatitis. Clin Liver Dis 2003; 7: 435-51. (Review article includes discussion of amiodarone and mechanisms of hepatic injury). 12879993
Iba-Ba J, Tilea M, Balligand JL, Lefebvre C. [Amiodarone liver toxicity about two cases and review of literature] Rev Med Interne 2004; 25: 386-9. French. PMID: 15110957 (80 year old woman and 83 year old man taking amiodarone for 5-6 years developed liver injury [bilirubin not given, ALT 5.6 times ULN and normal, Alk P 1.7 and 1.6 times ULN], liver histology showing steatosis, inflammation, fibrosis and Mallory bodies, one patient died of esophageal variceal hemorrhage and the other improved after stopping).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, none were attributed to amiodarone). 15390328
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, Garcia-Ruis E, Garcia-Munoz G, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network reported 461 cases of drug induced liver disease, amiodarone was not listed among the 20 most common causes). 16083708
Robinson E, Bissett J, Smith ES 3rd. Amiodarone toxicity and surveillance. J Ark Med Soc 2005; 101: 308-9.15839319
Mitchell LB, Exner DV, Wyse DG, Connolly CJ, Prystai GD, Bayes AJ, Kidd WT, et al. Prophylactic oral amiodarone for the prevention of arrhythmias that begin early after revascularization, valve replacement, or repair: PAPABEAR: a randomized controlled trial. JAMA 2005; 294: 3093-100. (299 patients received oral amiodarone for 6 days before and 6 days after coronary artery bypass surgery; no liver toxicity mentioned). 16380589
Grieco A, Forgione A, Miele L, Vero V, Greco AV, Gasbarrini A, Gasbarrini G. Fatty liver and drugs. Eur Rev Med Pharmacol Sci 2005; 9: 261-3. (Review of different causes of drug induced fatty liver, separating drugs into those that cause steatosis and steatohepatitis from those that exacerbate nonalcoholic fatty liver and those that cause steatosis sporadically). 16237810
Maker AV, Orgill DP. Rapid acute amiodarone-induced hepatotoxicity in a burn patient. J Burn Care Rehabil 2005; 26: 341-3. (54 year old man with severe burns developed marked ALT elevations [1303 U/L] with no jaundice after 5 days of iv amiodarone therapy, resolving rapidly on stopping). 16006841
Oikawa H, Maesawa C, Sato R, Oikawa K, Yamada H, Oriso S, Ono S, et al. Liver cirrhosis induced by long-term administration of a daily low dose of amiodarone: a case report. World J Gastroenterol 2005; 11: 5394-7. (85 year old man on oral amiodarone [200 mg/day] for 7 years presented with cirrhosis [bilirubin 1.2 mg/dL, ALT 35 U/L, Alk P 452 U/L]; despite stopping drug, he developed worsening hepatic decompensation and died 4 months later). 16149155
Puli SR, Fraley MA, Puli V, Kuperman AB, Alpert MA. Hepatic cirrhosis caused by low-dose oral amiodarone therapy. Am J Med Sci 2005; 330: 257-61. (63 year old man developed ascites 22 months after starting oral amiodarone therapy [200 mg/day] [bilirubin 1.4 mg/dL, ALT 82 U/L], biopsy showed cirrhosis and microvesicular fat). 16284489
Rätz Bravo AE, Drewe J, Schlienger RG, Krähenbühl S, Pargger H, Ummenhofer W. Hepatotoxicity during rapid intravenous loading with amiodarone: Description of three cases and review of the literature. Crit Care Med 2005; 33: 128-34; discussion 245-6. (3 case reports and review of 25 cases of hepatotoxicity from iv amiodarone in the literature; all 3 cases had periods of instability during or after surgery, ALT and AST rose to >50 times ULN with increases in INR and mild jaundice, findings that may represent acute heart failure; recommend monitoring during iv use of amiodarone and stopping for marked ALT elevations). 15644659
Galan MV, Potts JA, Silverman AL, Gordon SC. The burden of acute nonfulminant drug-induced hepatitis in a United States tertiary referral center [corrected]. J Clin Gastroenterol 2005; 39: 64-7. Erratum in: J Clin Gastroenterol 2005; 39: 176. PMID: 15599214 (Among 32 cases of drug induced liver disease identified between 1993-2002, amiodarone was the most common cause [21%]). 15599214
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports [89% from the US]; 21 drugs were associated with more than 50 cases: amiodarone ranked 8th with ~70 cases). 16054882
Connolly SJ, Dorian P, Roberts RS, Gent M, Bailin S, Fain ES, Thorpe K, et al.; Optimal Pharmacological Therapy in Cardioverter Defibrillator Patients (OPTIC) Investigators. Comparison of beta-blockers, amiodarone plus beta-blockers, or sotalol for prevention of shocks from implantable cardioverter defibrillators: the OPTIC Study: a randomized trial. JAMA 2006; 295: 165-71. (140 patients received oral amiodarone for one year of whom 5.7% developed thyroid and 5% pulmonary dysfunction; no mention of liver injury). 16403928
Da Costa A, Thevenin J, Roche F, Romeyer-Bouchard C, Abdellaoui L, Messier M, et al.; Loire-Ardeche-Drome-Isere-Puy-de-Dome Trial of Atrial Flutter Investigators. Results from the Loire-Ardeche-Drome-Isere-Puy-de-Dome (LADIP) trial on atrial flutter, a multicentric prospective randomized study comparing amiodarone and radiofrequency ablation after the first episode of symptomatic atrial flutter. Circulation 2006; 114: 1676-81. (Prospective trial of 104 elderly patients given oral amiodarone or radiofrequency ablation for atrial flutter; no mention of hepatic toxicity during an average of 13 months of therapy). 17030680
Waldhauser KM, Török M, Ha HR, Thomet U, Konrad D, Brecht K, Follath F, et al. Hepatocellular toxicity and pharmacological effect of amiodarone and amiodarone derivatives. J Pharmacol Exp Ther 2006; 319: 1413-23. (In vitro study of amiodarone and its derivatives for effects on hepatocytes and mitochondria). 16971508
Kum LC, Chan WW, Hui HH, Wong GW, Ho SS, Sanderson JE, Yu CM, Fung JW. Prevalence of amiodarone-related hepatotoxicity in 720 Chinese patients with or without baseline liver dysfunction. Clin Cardiol 2006; 29: 295-9. (Retrospective chart review on 720 patients receiving oral amiodarone [100-300 mg/day] for an average of 2 years, only 4 patients [0.6%] stopped therapy because of liver test abnormalities, but ~4% developed abnormal ALT [2 times ULN or higher]). 16881537
Kochiadakis GE, Igoumenidis NE, Hamilos ME, Marketou ME, Chlouverakis GI, Vardas PE. A comparative study of the efficacy and safety of procainamide versus propafenone versus amiodarone for the conversion of recent-onset atrial fibrillation. Am J Cardiol 2007; 99: 1721-5. (In a prospective clinical trial, 92 patients received iv amiodarone for conversion of atrial fibrillation, no hepatic dysfunction mentioned). 17560882
Singh BN, Connolly SJ, Crijns HJ, Roy D, Kowey PR, Capucci A, Radzik D, et al.; EURIDIS and ADONIS Investigators. Dronedarone for maintenance of sinus rhythm in atrial fibrillation or flutter. N Engl J Med 2007; 357: 987-99. (Prospective study of a benzofuran derivative of amiodarone given to 828 patients for up to one year, abnormalities in liver tests were reported in 12.2% of dronedarone and 13.6% of placebo recipients). 17804843
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, Guarner C, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25:1401-9. (Population based survey of 126 cases of acute drug induced liver injury in Spain between 1993-1999 calculated relative risk of injury compared to the general population as 12.3 for amiodarone [but, n=3] with estimated incidence of 7.0 per 100,000 patient years). 17539979
Zimetbaum P. Amiodarone for atrial fibrillation. N Engl J Med 2007; 356: 935-41. (Clinical therapeutics article about use of amiodarone in atrial fibrillation, a non-FDA approved but clearly effective therapy; recommends that amiodarone be used carefully with regular monitoring for side effects). 17329700
Rizzioli E, Incasa E, Gamberini S, Savelli S, Zangirolami A, Tampieri M, Manfredini R. Acute toxic hepatitis after amiodarone intravenous loading. Am J Emerg Med 2007; 25: 1082.e1-4. (79 year old woman developed marked ALT elevations [3387 U/L] starting within a few hours of iv amiodarone infusions followed by mild jaundice [bilirubin 2.2 mg/dL], with rapid resolution; possibly due to ischemic hepatitis from acute heart failure). 18022508
Sharma JR, Sathanandam S, Rao SP, Acharya S, Flood V. Ventricular tachycardia in acute fulminant myocarditis: medical management and follow-up. Pediatr Cardiol 2007;29:416-9. (17 month old girl with ventricular tachycardia, developed marked elevations of ALT [5073 U/L] and LDH after iv amiodarone, resolving rapidly with stopping). 17876653
Vassallo P, Trohman RG. Prescribing amiodarone: an evidence-based review of clinical indications. JAMA 2007; 298: 1312-22. (Review of use of amiodarone with summary of side effects: elevated enzymes in 15 to 30% of patients on long term therapy; hepatitis or cirrhosis in less than 3%, 0.6% annually). 17878423
Chen YY, Chen CY, Leung KK. Acute pancreatitis and amiodarone: a case report. World J Gastroenterol 2007; 13: 975-7. (66 year old woman developed mild pancreatitis without liver injury 3 months after starting oral amiodarone [100-200 mg/day]). 17352036
Collins AM, Winter DC, McCormick AP, Cottell DC, Geoghegan JG. Amiodarone hepatotoxicity complicating obstructive jaundice due to ampullary cancer. Hepatobiliary Pancreat Dis Int 2007; 6: 435-7. (65 year old man developed jaundice which was attributed to ampullary cancer, but liver biopsy showed amiodarone-like changes in addition; patient had received 200 mg/day for 5 years). 17690045
Kang HM, Kang YS, Kim SH, Seong JK, Kang DY, Lee HY, Lee BS. Amiodarone-induced hepatitis and polyneuropathy. Korean J Intern Med 2007; 22: 225-9. (75 year old man developed polyneuropathy and liver disease after 1.5 years of therapy with amiodarone). 17939344
Dedhia V, Munsi SC. Acute amiodarone hepatotoxicity. Indian Heart J 2007; 59: 491-3.19151464
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 cases [~1%] were attributed to amiodarone: Case 1). 18955056
Cataldi A, Gonella D, Robutti N, Siri M, Buonocore S, Odetti P. Hepatotoxicity after intravenous amiodarone. Aging Clin Exp Res 2008; 20: 593-6. (77 year old with atrial fibrillation and heart failure, given one day of iv amiodarone and found to have marked increase in ALT levels peaking at 4200 U/L on day 5 (bilirubin 1.9 mg/dL), resolving 2 weeks after stopping). 19179845
Babatin M, Lee SS, Pollak PT. Amiodarone hepatotoxicity. Curr Vasc Pharmacol 2008; 6: 228-36. (Review of hepatotoxicity of amiodarone; ALT elevations occur in 7-24% of patients, depending upon definition and frequency of testing; clinically apparent liver injury in 1-3%, but variable latency and presentation; no clear guidelines on reliability of monitoring). 18673162
Chan AL, Hsieh HJ, Hsieh YA, Lin SJ. Fatal amiodarone-induced hepatotoxicity: a case report and literature review. Int J Clin Pharmacol Ther 2008; 46: 96-101. (72 year old developed acute liver failure starting one day after second dose of iv amiodarone for rapid atrial fibrillation with ALT rising from 44 to 1316 U/L, followed by hepatic and renal failure and death 3 weeks later). 18218290
Hoteit MA, Sanchez W. A bright liver. Clin Gastroenterol Hepatol 2008;6: xxii. (CT image in 72 year old woman on amiodarone for several years with mild enzyme elevations but prolonged prothrombin time showed bright liver indicative of iodine accumulation). 18514037
Li L, Yang J, Ding JW. [Acute amiodarone-induced hepatotoxicity in a patient]. Zhonghua Xin Xue Guan Bing Za Zhi 2008; 36: 464. Chinese. PMID: 19100047
Huang X, Yang Y, Zhu J, Gao X, Wang G, Tan H, Liang Y, Li J. Clinical applications and acute hepatotoxicity of intravenous amiodarone. J Int Med Res 2009; 37: 1928-36. (Retrospective chart review of 1214 patients who received intravenous amiodarone; 12% had liver test abnormalities, but most were mild; 1.1% were severe [ALT >10 times ULN: 446-2554 U/L], all recovered within 5 to 18 days). 20146893
Mattar W, Juliar B, Gradus-Pizlo I, Kwo PY. Amiodarone hepatotoxicity in the context of the metabolic syndrome and right-sided heart failure. J Gastrointestin Liver Dis 2009; 18: 419-23. (Among 409 patients treated with amiodarone for 60 days or more, 8 developed hepatotoxicity [ALT elevations] but none died or developed cirrhosis; all recovered, 5 after stopping and 3 with dose modification). 20076813
Hug BL, Lipsitz SR, Seger DL, Karson AS, Wright SC, Bates DW. Mortality and drug exposure in a 5-year cohort of patients with chronic liver disease. Swiss Med Wkly 2009; 139: 737-46. (Retrospective cohort study of all hospital outpatients seen at two Boston hospitals between 2002-7 using ICD9 codes; 1.1 million patients, 20,158 [1.7%] with chronic liver disease, mean age 52 years, 55% men, chronic hepatitis C in 30%, B in 7.5% and alcohol in 8.4%, 5 drugs were associated with a higher mortality rate, one being amiodarone). 19924579
Raja K, Thung SN, Fiel MI, Chang C. Drug-induced steatohepatitis leading to cirrhosis: long-term toxicity of amiodarone use. Semin Liver Dis 2009; 29: 423-8. (77 year old woman developed ascites 3 years after starting amiodarone [200 g/day] [bilirubin 0.6 mg/dL, ALT 32 U/L, Alk P 216 U/L, albumin 3.9 g/dL, INR 1.2, ANA 1:640], biopsy showing fibrosis and Mallory bodies, moderate steatosis). 19826976
Llanos L, Moreu R, Peiró AM, Pascual S, Francés R, Such J, Horga JF, et al. Causality assessment of liver injury after chronic oral amiodarone intake. Pharmacoepidemiol Drug Saf 2009; 18: 291-300. (Analysis of 39 cases of amiodarone hepatotoxicity from literature; mean age 69 years, latency 2-3 years [ALT 188 U/L, Alk P 265 U/L], 19 [48%] had cirrhosis, 15 [38%] died; Bayesian analysis suggests that amiodarone is cause of ALT elevations in only 50% of cases, ALT above 3 times ULN occurring in 1.7% of treated patients, 0.8% of controls). 19165760
Atiq M, Davis JC, Lamps LW, Beland SS, Rose JE. Amiodarone induced liver cirrhosis. Report of two cases. J Gastrointestin Liver Dis 2009; 18: 233-5. (Review of literature on amiodarone hepatotoxicity using Bayesian approach to assess likelihood of injury; modeling indicates that 2.3% of treated patients will develop liver test abnormalities [but only half related to amiodarone] and 0.5% clinically significant injury). 19565059
Kraus MS, Thomason JD, Fallaw TL, Calvert CA. Toxicity in Doberman Pinchers with ventricular arrhythmias treated with amiodarone (1996-2005). J Vet Intern Med 2009; 23: 1-6. (Among 22 dogs with dilated cardiomyopathy receiving amiodarone, 3 developed acute toxicities with ALT 841-1128 U/L resolving rapidly; 43% developed toxicity during maintenance therapy with ALT 427-2306 U/L, bilirubin 1.8-2.7 mg/dL; no hepatic histology). 19175714
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug-induced liver injury, none of which were attributed to amiodarone). 20949552
Arkun A, Van Deusen SK, Grau T, Birkhahn RH. Hepatic dysfunction and neurotoxicity in a patient receiving long-term low-dose amiodarone therapy. J Emerg Med 2010; 38: 337-9. (90 year old man developed nausea and confusion 18 months after starting amiodarone [200 mg/day] [bilirubin 1.7 mg/dL, ALT 32 U/L, Alk P 189 U/L, ammonia 127 μmol], rapid resolution of symptoms on stopping). 18757154
Gassanov N, Caglayan E, Erdmann E, Er F. [Amiodarone-induced liver dysfunctions]. Dtsch Med Wochenschr 2010; 135: 1372-4. German. PMID: 20589584 (64 year old woman developed fatigue and abdominal pain 17 months after starting oral amiodarone [200 mg/day] [bilirubin normal, ALT 263 U/L, GGT 71 U/L], resolving upon stopping).
Pollak PT. How toxic is amiodarone to the liver? J Gastrointestin Liver Dis 2010; 19: 11-3. (Commentary on liver injury from amiodarone: "amiodarone appears to be as safe or safer than alcohol"). 20361068
Ishida S, Sugino M, Hosokawa T, Sato T, Furutama D, Fukuda A, Kimura F, Kuwabara H, Shibayama Y, Hanafusa T. Amiodarone-induced liver cirrhosis and parkinsonism: a case report. Clin Neuropathol 2010; 29: 84-8. (67 year old man developed hand tremor, confusion and liver test abnormalities 2 years after starting amiodarone [200 mg daily] [bilirubin 1.9 mg/dL, ALT 167 U/L, Alk P 463 U/L, ammonia 161 μg/dL], dying within days of presentation and autopsy showing cirrhosis with steatosis and Mallory bodies and brain changes of Parkinson disease). 20175957
Verhovez A, Elia F, Riva A, Ferrari G, Aprà F. Acute liver injury after intravenous amiodarone: a case report. Am J Emerg Med 2011; 29: 843.e5-6. (82 year old woman with heart failure and rapid atrial fibrillation developed serum enzyme elevations within 24 hours of starting iv amiodarone [ALT 1614 U/L], which fell to normal within 9 days of stopping). 20870371
von Vital JM, Karachristos A, Singhal A, Thomas R, Jain A. Acute amiodarone hepatotoxicity after liver transplantation. Transplantation 2011; 91: e62-4. (64 year old man with end stage liver disease from NASH and liver cancer developed ALT elevations [bilirubin 13.4 mg/dL, ALT 2028 U/L, Alk P 104 U/L] 7 days after liver transplantation while receiving iv amiodarone, resolving rapidly when it was stopped and with no other cause found). 21475067
In brief: FDA warning on dronedarone (Multaq). Med Lett Drugs Ther 2011; 53(1359): 17. (Warning from FDA of several cases of severe liver injury and liver failure, two requiring liver transplantation after 4.5 and 6 months of amiodarone therapy). 21383666
Gluck N, Fried M, Porat R. Acute amiodarone liver toxicity likely due to ischemic hepatitis. Isr Med Assoc J 2011; 13: 748-52. (Comparison of clinical and biochemical features of 25 cases of acute liver injury due to iv amiodarone, with 25 cases of acute ischemic hepatitis showed similarities in risk factors, associated conditions, ALT and LDH elevations and time to resolution, suggesting ischemic hepatitis as the actual cause of reported acute amiodarone injury). 22332445
Joghetaei N, Weirich G, Huber W, Büchler P, Estner H. Acute liver failure associated with dronedarone. Circ Arrhythm Electrophysiol 2011; 4: 592-3. (70 year old woman developed jaundice 6 months after starting dronedarone for atrial fibrillation [peak bilirubin 30.3 mg/dL, ALT and Alk P not provided], with progressive hepatic failure leading to emergency liver transplantation 20 days after presentation). 21846890
Sung PS, Yoon SK. Amiodarone hepatotoxicity. Hepatology 2012; 55: 325-6. (72 year old man developed ascites 5 years after starting amiodarone [200 mg daily] for atrial fibrillation [bilirubin 2.3 mg/dL, ALT 237 U/L, Alk P 137 U/L, INR 1.32], CT scan showing hyperdense liver and biopsy showing cirrhosis). 21898482
Grecian R, Ainslie M. Acute hepatic failure following intravenous amiodarone. BMJ Case Rep 2012; 2012. PMID: 23257638 (73 year old man with ventricular arrhythmias developed liver injury within 24 hours of switching from oral to iv amiodarone [bilirubin 5.6 mg/dL, ALT 2421 U/L, Alk P 115 U/L], with rapid improvement on stopping).
Kicker JS, Haizlip JA, Buck ML. Hepatotoxicity after continuous amiodarone infusion in a postoperative cardiac infant. J Pediatr Pharmacol Ther 2012; 17: 189-95. (8 month old girl developed liver injury within 4 days of starting iv amiodarone infusions [bilirubin 3.8 mg/dL, ALT 922 U/L, INR 4.3], resolving within 2-3 weeks of stopping). 23118673
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73.22379337
(Summary of 2 years of spontaneous adverse event reporting in Korea; of 9360 reports, 567 were liver related, but none were attributed to amiodarone) .
Lahbabi M, Aqodad N, Ibrahimi A, Lahlou M, Aqodad H. Acute hepatitis secondary to parenteral amiodarone does not preclude subsequent oral therapy. World J Hepatol 2012; 4: 196-8. (29 year old woman developed liver test abnormalities within 24 hours of starting iv amiodarone [bilirubin normal, ALT 1050 U/L, Alk P 200 U/L], resolving within 1-2 weeks despite continuing amiodarone orally). 22761971
Ben Chaabane N, Hellara O, Safer L, Melki W, Bdioui F, Zakhama A, Saffar H. Cirrhosis with increased density of the liver: amiodarone-induced hepatotoxicity. Tunis Med 2012; 90: 487-8. (70 year old woman developed weight loss and hepatomegaly having taken amiodarone [200 mg daily] for 15 years [bilirubin not given, ALT 100 U/L, Alk P 347 U/L], liver biopsy showing cirrhosis and steatosis, lab tests improving upon stopping amiodarone). 22693093
Thiele RH, Williams J, Moylan CA, Rao SV, Bennett-Guerrero E. CASE 6--2012: suspected amiodarone hepatotoxicity after cardiac surgery. J Cardiothorac Vasc Anesth 2012; 26: 729-32. (57 year old man developed rapid atrial fibrillation 3 days after coronary artery bypass surgery and had liver injury within 24 hours of starting amiodarone [bilirubin not given, peak ALT 8197 U/L, INR 2.3, CK 4787], eventually resolving rapidly once amiodarone was stopped). 22516469
Rao U, Agarwal A. Amiodarone-induced acute hepatotoxicity. Eur J Clin Pharmacol 2012; 68: 449-50. (44 year old man with heart failure and rapid atrial fibrillation developed hypotension and liver injury within 24 hours of starting iv amiodarone [bilirubin 2.6 mg/dL, ALT 4428 U/L, Alk P 109 U/L], resolving within 10 days of stopping). 21989920
Akbal E, Batgi H, Koçak E, Canatan T, Köklü S. Low-dose amiodarone-induced fatal liver failure. Drug Chem Toxicol 2012 Epub. PMID: 22356138 (80 year old man developed jaundice one month after starting amiodarone in a dose of 400 mg daily [bilirubin 3.6 mg/dL, ALT 1240 U/L, LDH 3170 U/L, Alk P 99 U/L] and died one day later after a cardiopulmonary arrest).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 1 case attributed to amiodarone). 23419359
Cimic A, Sirintrapun J. Amiodarone hepatotoxicity with absent phospholipidosis and steatosis: a case report and review of amiodarone toxicity in various organs. Case Rep Pathol 2013; 2013: 201095. (33 year old woman with congenital heart disease developed liver test abnormalities after several years of therapy with amiodarone [bilirubin normal, ALT 188 U/L, Alk P normal], liver biopsy showing ballooning degeneration, Mallory bodies, inflammation and fibrosis, but no steatosis; after stopping, enzymes fell to normal). 23762711
Nasser M, Larsen TR, Waanbah B, Sidiqi I, McCullough PA. Hyperacute drug-induced hepatitis with intravenous amiodarone: case report and review of the literature. Drug Healthc Patient Saf 2013; 5: 191-8. (88 year old man with atrial fibrillation developed liver test abnormalities after receiving 960 mg of amiodarone iv over 10 hours [bilirubin 0.9 mg/dL, ALT 1048 U/L], resolving within 7 days of stopping). 24109195
Cho YS, Han JH, Chae HB, Kim JS, Kang KM, Park SM, Lim JC. [A case of simultaneously occurred amiodarone-induced hepatitis and hypothyroidism]. Korean J Gastroenterol 2013; 62: 59-63. (65 year old woman with atrial fibrillation developed liver and thyroid test abnormalities 9 months after starting amiodarone [bilirubin 0.6 mg/dL, ALT 399 U/L, GGT 68 U/L, TSH 17.3 mU/L], resolving once amiodarone was stopped). 23954962
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9.24552865
(Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to amiodarone).
Kim HL, Seo JB, Chung WY, Kim SH, Kim MA, Zo JH. The incidence and predictors of overall adverse effects caused by low dose amiodarone in real-world clinical practice. Korean J Intern Med 2014; 29: 588-96. (Among 930 patients with arrhythmia treated with low doses of amiodarone, 154 [17%] had adverse events which were liver related in 20 [2.2%] but no details provided). 25228834
Amacher DE, Chalasani N. Drug-induced hepatic steatosis. Semin Liver Dis 2014; 34: 205-14. (Review of the drugs that cause hepatic steatosis including amiodarone, valproate, methotrexate, tamoxifen, cancer chemotherapies and antiretroviral agents). 24879984
Kim BB, Kim DM, Choi DH, Chung JW, Koh YY, Chang KS, Hong SP. Amiodarone toxicity showing high liver density on CT scan with normal liver function and plasma amiodarone levels in a long-term amiodarone user. Int J Cardiol 2014; 172: 494-5. (75 year old woman with recurrent atrial fibrillation developed tremor, nausea and vomiting 26 months after starting amiodarone [400 mg daily] and routine CT scan showed high density of the liver despite normal liver tests [ALT 32, AST 28 U/L], the symptoms resolving with stopping amiodarone). 24485640
Rabinowich L, Shibolet O. Drug induced steatohepatitis: an uncommon culprit of a common disease. Biomed Res Int 2015; 2015: 168905. (Review of the drugs that cause hepatic steatosis including amiodarone, valproate, methotrexate, tamoxifen, cancer chemotherapies and antiretroviral agents). 26273591
Buggey J, Kappus M, Lagoo AS, Brady CW. Amiodarone-induced liver injury and cirrhosis. ACG Case Rep J 2015; 2: 116-8. (80 year old woman developed fatigue 3.5 years after starting amiodarone and was found to have cirrhosis [bilirubin 1.9 mg/dL, ALT 54 U/L, AST 94 U/L, Alk P 200 U/L], with hepatic decompensation and death within 2 days). 26157932
Stratton A, Fenderson J, Kenny P, Helman DL. Severe acute hepatitis following intravenous amiodarone: a case report and review of the literature. Acta Gastroenterol Belg 2015; 78: 233-9. (80 year old man developed marked increases in ALT levels within 24 hours of starting iv amiodarone [bilirubin rising from 0.5 to 1.6 mg/dL, ALT 44 to 3969 U/L, Alk P 127 U/L] resolving rapidly with stopping infusions). 26151694
Mudalel ML, Dave KP, Hummel JP, Solga SF. N-acetylcysteine treats intravenous amiodarone induced liver injury. World J Gastroenterol 2015; 21: 2816-9. (65 year old woman with cardiogenic shock and atrial fibrillation developed marked ALT elevations after receiving iv amiodarone [ALT 1541 U/L], which decreased rapidly with infusions of N-acetylcysteine). 25759554
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 76 inpatients with hepatitis of unknown cause enrolled in a prospective case-cohort surveillance study between 2002 and 2011, 7 [9%] were attributed to amiodarone, which was being taken by only 10 of 377 controls [2.7%] yielding an odds ratio of 5.5). 25444550
Li JG, Yang TC, Yu DM, Ren TH. Fatal acute liver failure after intravenous amiodarone administration. J Formos Med Assoc 2015; 114: 294-6. (Authors report two cases of acute liver failure in patients given iv amiodarone without specific details and summarize 5 fatal instances from the published literature). 23953514
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases were attributed to amiodarone). 25754159
Chen CC, Wu CC. Acute hepatotoxicity of intravenous amiodarone: case report and review of the literature. Am J Ther 2016; 23: e260-3. (57 year old man with coronary artery disease, diabetes and hepatitis B developed marked increases in AST levels within 2 days of starting amiodarone infusions [bilirubin 0.8 mg/dL, AST 4374 U/L, Alk P 108 U/L] falling into the normal range within 3 weeks of stopping the infusions and despite continuing oral amiodarone). 25259952
Bucco S, Arazzi M, Giunta F, Grabocka X, Longo MO, Silvestri S, Spetrino N, et al. [Acute hepatotoxicity from intravenous amiodarone in a patient on hemodialysis]. G Ital Nefrol 2016; 33. pii: PMID: 26913742 (74 year old woman on chronic hemodialysis developed rapid atrial fibrillation and was found to have marked liver test elevations within 24 hours of starting intravenous amiodarone [bilirubin 0.7 mg/dL, ALT 1139, LDH 3079 U/L, Alk P 120 U/L] which fell rapidly to normal within 7 days of stopping).
Hashmi A, Keswani NR, Kim S, Graham DY. Hepatic dysfunction in patients receiving intravenous amiodarone. South Med J 2016; 109: 83-6. (Among 1510 patients treated with iv amiodarone over a 7-year period in a retrospective chart review, 77 [5%] developed ALT elevations of varying severity [peak 37 to 10,006 U/L] and 17 [22%] died within 30 days, but none died of the liver injury). 26840961
Paudel R, Dogra P, Suman S, Acharya S, Matta J. Acute liver and renal failure: a rare adverse effect exclusive to intravenous form of amiodarone. Case Rep Crit Care. 2016;2016:5232804. (65 year old man with coronary artery disease and cardiac pacemaker received 24 hours of iv amiodarone and developed marked elevations in ALT and AST which peaked at 4450 U/L and 8981U/L at 36 hours [bilirubin and Alk P not provided] with oliguria and rise in creatinine, and had rapid recovery on stopping infusion and later tolerating oral amiodarone). 27672457
Rankin S, Elder DH, Ogston S, George J, Lang CC, Choy AM. Population-level incidence and monitoring of adverse drug reactions with long-term amiodarone therapy. Cardiovasc Ther. 2017;35. (Retrospective analysis of electronic health records of 1413 patients on long-term amiodarone found that only 46% were being monitored with ALT determinations as recommended, and 17% had no ALT results). 28276175
Jaiswal P, Attar BM, Yap JE, Devani K, Jaiswal R, Wang Y, Szynkarek R, et al. Acute liver failure with amiodarone infusion: A case report and systematic review. J Clin Pharm Ther. 2018;43:129-133. (79 year old woman with atrial flutter received iv amiodarone for 24 hours and 1 day later developed mental status changes with peak ALT 3096 U/L, AST 6712 U/L, bilirubin 2.8 mg/dL, protime 27.9 sec on day 3, recovering rapidly with normal laboratory values 3 weeks later). 28714083
Nicot F, Procopi N, Nguyen LS. Intravenous amiodarone-induced acute liver failure in cardiac surgery intensive care unit. Therapie. 2018;73:355-357.. (74 year old woman developed rapid atrial fibrillation 4 days after aortic value replacement which was treated with iv amiodarone and two days later she had encephalopathy and coagulopathy, ALT ~3050 U/L; when fibrillation recurred, she was treated again and again developed acute liver injury [ALT 3700 U/L], recovering rapidly upon stopping again). 29395301
Guzmán Ramos MI, Romero García T, Márquez Saavedra E, Suárez García E, Martínez Castillo R. Dronedarone-induced liver injury. A case report. Gastroenterol Hepatol. 2018;41:636-638. (78 year old woman with heart disease and atrial fibrillation developed fatigue and jaundice 6 months after starting dronedarone [bilirubin 13.6 mg/dL, ALT 453 U/L, Alk P not provided] with progressive hepatic encephalopathy, ascites, and death 18 days later). 29452933
Gayam V, Khalid M, Dahal S, Garlapati P, Gill A, Alex R, Mansour M. Fatal acute liver failure with intravenous amiodarone: a case report and literature review. Gastroenterology Res. 2018;11:62-63. (53 year old African American with end-stage renal disease and atrial flutter was treated with iv amiodarone for 3 days when found to have acute liver injury [ALT 1500 U/L, AST 3000 U/L, INR 24], and despite stopping infusion, developed multiorgan failure and died a few days later). 29511409
Diab OA, Kamel J, Abd-Elhamid AA. Predictors of intravenous amiodarone induced liver injury. Egypt Heart J. 2017;69:45-54. (Among 180 patients who received iv amiodarone at a single Egyptian referral center, factors found to be risk factors in 90 patients who developed ALT elevations included male sex, pre-existing cardiomyopathy, and chronic liver disease with baseline serum bilirubin levels being a significant and quantitative risk factor for severity). 29622954
Tsuda T, Tada H, Tanaka Y, Nishida N, Yoshida T, Sawada T, Sakata K, et al. Amiodarone-induced reversible and irreversible hepatotoxicity: two case reports. J Med Case Rep. 2018;12:95. (Two Japanese men presented with liver disease, the first after 17 years of amiodarone [150 mg daily] had cirrhosis and died of hepatic failure, the second after 3 years of amiodarone [200 mg daily] had bridging fibrosis and the liver injury improved slowly after discontinuation). 29653592
Keng LT, Liao MT. Amiodarone-induced hepatic and pulmonary toxicity. Postgrad Med J. 2018; 94:603. (An 88 year old woman on amiodarone for 5 months for atrial flutter developed abdominal pain due to acute cholecystitis while CT scan also showed a bright liver and pleural atelectasis compatible with concurrent amiodarone liver and pulmonary toxicity). 29743186
Grimaldi-Bensouda L, Wedemeyer H, Wiegand J, Lohse AW, Benichou J, Rossignol M, Larrey D, et al; PGRx-ALI study group. Dronedarone, amiodarone and other antiarrhythmic drugs, and acute liver injuries: a case-referent study. Int J Cardiol. 2018;266:100-105. (Comparison of 252 cases of suspected drug-induced liver injury collected by a network of 59 centers in Germany between 2010 and 2014 vs 1081 age and sex matched concurrent controls, showed that dronedarone was used by 1.2% [3 cases] vs 0.4% and amiodarone by 2.4% [6 cases] vs 0.6%), the “adjusted” odds ratio being slightly higher for amiodarone). 29887424
Dilaveris P, Tousoulis D. Do not condemn solely dronedarone for acute liver injury: It's a class effect. Int J Cardiol. 2018;266:149-150.. (Editorial in response to Grimaldi-Bensouda [2018] argues that while both dronedarone and amiodarone can cause liver injury, it is a class effect and dronedarone may be better tolerated than amiodarone). 29887433
Haddad FG, Mulrooney S. A Shiny Liver! Gastroenterology. 2019;156:1580-1581.. (86 year old woman with heart failure on multiple medications was found to have abnormal liver tests [bilirubin 1.5 mg/dL, ALT 176 U/L, Alk P 104, INR 3.0, albumin 2.6 g/dL] with a bright liver on CT scan, the diagnosis of amiodarone induced liver injury was made and she improved after its discontinuation). 30240666
Cherchi M, Salmón Z, Ortiz F, Riancho JA. Severe liver toxicity by intravenous amiodarone. Med Clin (Barc). 2019;153:258-259. English, Spanish. PMID: 30595368 (59 year old man with heart failure and atrial flutter was treated with iv amiodarone and after 3 days developed abdominal [bilirubin 4.5 mg/dL, ALT 5026 U/L, AST 2353 U/L, INR 5.6, ammonia elevated], with rapid improvement and normal values 2 weeks after stopping).
Huang CH, Lai YY, Kuo YJ, Yang SC, Chang YJ, Chang KK, Chen WK. Amiodarone and risk of liver cirrhosis: a nationwide, population-based study. Ther Clin Risk Manag. 2019;15:103-112. (Among 8081 users of amiodarone in the Taiwan National Health Insurance Research Database between 1997 and 2013, 98 [1.2%] developed cirrhosis compared to 307 [0.95%] of 32,324 controls, a difference that was not significant after “adjustment” for possible confounders). 30666120
Bratton H, Alomari M, Al Momani LA, Aasen T, Young M. prolonged jaundice secondary to amiodarone use: a case report and literature review. Cureus. 2019;11:e3850. (76 year old woman with short gut syndrome on total parenteral nutrition and atrial fibrillation treated with amiodarone [unknown dose or duration] developed jaundice [bilirubin 26.7 mg/dL, ALT 74 U/L, Alk P 99 U/L, INR 1.4] with liver biopsy showing steatohepatitis; no follow up provided). 30891390
Mohamed M, Al-Hillan A, Flores M, Kaunzinger C, Mushtaq A, Asif A, Hossain M. Concomitant acute hepatic failure and renal failure induced by intravenous amiodarone: a case report and literature review. Gastroenterology Res. 2020;13:40-43. (67 year old man with coronary artery disease presented with chest pain and atrial flutter and received iv amiodarone which resulted in marked worsening of baseline liver and renal abnormalities [bilirubin 1.5 rising to 3.9 mg/dL, ALT 208 to 2422 U/L, creatinine 1.8 to 3.2, INR 1.4 to 2.3] which worsened for a few days after stopping [ALT 9020 U/L, creatinine 4.3 mg/dL] but then gradually fell to baseline). 32095172
Essrani R, Mehershahi S, Essrani RK, Ravi SJK, Bhura S, Sudhakaran A, Hossain M, et al. Amiodarone-induced acute liver injury. Case Rep Gastroenterol. 2020;14:87-90. (60 year old man was admitted with rapid atrial fibrillation and treated with iv amiodarone which was stopped after 50 hours when blood tests revealed ALT 1643 U/L, AST 3254 U/L, LDH 2254 U/L, direct bilirubin 5.1, and INR 2.5, with rapid resolution within 7 days of stopping). 32231507
Khan ZH, Mukhtar K, Ahmed MM, Zaidi SR, Abd Algayoum R. Dronedarone-mediated acute hepatic and renal toxicity. Cureus. 2020;12:e9611. (86 year old man with rapid atrial fibrillation despite long term amiodarone therapy was given 3 doses of dronedarone [amount not provided] without change in rapid heart rate leading to cardioversion 24 hours after which serum ALT was 3151 U/L, AST 3930 U/L, Alk P 144 U/L, INR 6.1 and creatinine 5.4 mg/dL, which then fell towards normal with no further therapy). 32923213
Lee FY, Wong HS, Chan HK, Mohamed Ali N, Abu Hassan MR, Omar H, Abdul Mutalib NA. Hepatic adverse drug reactions in Malaysia: An 18-year review of the national centralized reporting system. Pharmacoepidemiol Drug Saf. 2020;29:1669-1679. (Among 2090 cases of hepatic adverse events reported to the Malaysian Adverse Drug Reactions Advisory Committee between 2000 and 2017, the most commonly implicated agents were drugs for tuberculosis [268: 13%], amiodarone [137: 6.6%], phenytoin [69: 3.3%] and simvastatin [64: 3.0%]). 33064335
Wu IU, Tsai JH, Ho CM. Fatal acute-on-chronic liver failure in amiodarone-related steatohepatitis: a case report. BMC Gastroenterol. 2021;21:50. (64 year old woman developed jaundice 2.5 years after starting amiodarone [bilirubin 11.7 mg/dL, ALT 108 U/L, INR 1.4, albumin 2.1], liver biopsy showing cirrhosis, inflammation and Mallory bodies; despite stopping amiodarone, she developed progressive liver failure and died). 33530924
Alanli R, Kucukay MB, Ozdemir O. Successful treatment of amiodarone-induced hepatic injury with N-acetylcysteine: A case report. Indian J Pharmacol. 2021;53:60-62. (83 year old woman with episodic ventricular fibrillation was treated with iv amiodarone and ALT levels rose quickly from normal to 427 U/L [bilirubin 1.9, INR 1.9] and ALT continued to rise to a peak of 1952 U/L despite stopping amiodarone, but then ALT levels began to improve while receiving N-acetylcysteine and were normal 14 days after onset). 33976000
Offenbacher J, Kazi F, Chen N, Mohamed M, Chacko J, Guttenplan N, Nguyen V. Immediate oral amiodarone re-challenge following the development of parenteral-induced acute liver toxicity. World J Emerg Med. 2021;12:321-323. (77 year old woman with coronary artery disease and atrial fibrillation was started on oral and switched to iv amiodarone, but developed abnormal liver tests within 8 hours of starting [ALT rising from 35 to 1841 U/L, INR from 1.2 to 2.6, Alk P 92 U/L and bilirubin 1.3 mg/dL] improving once switched back to oral amiodarone but soon thereafter died of septic shock from toxic megacolon). 34512831
González IA, Fuller LD, Zhang X, Papke DJ, Zhao L, Zhang D, Liao X, et al. Development of a scoring system to differentiate amiodarone-induced liver injury from alcoholic steatohepatitis. Am J Clin Pathol. 2022;157:434-442. (Comparison of histology from 17 cases of oral amiodarone-induced liver disease to 17 cases of alcoholic steatohepatitis found that amiodarone cases had less fat, neutrophilic inflammation, and ballooning degeneration compared to alcoholic steatohepatitis, and that pericellular fibrosis and Mallory bodies were more likely to be in zone 1 [periportal] in amiodarone cases). 34596220
You HS, Yoon JH, Cho SB, Choi YD, Kim YH, Choi W, Kang HC, et al. Amiodarone-induced multi-systemic toxicity involving the liver, lungs, thyroid, and eyes: a case report. Front Cardiovasc Med. 2022;9:839441. (61 year old woman with heart disease on amiodarone therapy for 3 years developed clinical and laboratory evidence of lung, liver, eye, and thyroid toxicity, all of which improved on stopping amiodarone and therapy with methimazole and 3 to 6 months of corticosteroids). 35295268
Jiang Z, Zhao C, Li X, Yi W, Yan R. Liver failure caused by intravenous amiodarone and effective intervention measures: A case report. J Clin Pharm Ther. 2022;47:1293-1296.. (76 year old Chinese man with multiple comorbidities and rapid atrial fibrillation was started on iv amiodarone, and at 24 hours liver tests were abnormal [bilirubin 3.0 mg/dL, ALT 262 U/L, Alk P 133 U/L] worsening at 48 hours [ALT 1379 U/L], followed by resolution once infusions were stopped; review of his medical history found similar episodes to iv amiodarone twice in the past). 35322453
Chan WPV, Hieger MA. Low-dose intravenous amiodarone-induced acute hepatic failure. Am J Ther. 2022;29:e364-e367.. (31 year old woman with alcohol withdrawal and seizures and obtundation who developed atrial fibrillation treated with a short, low-dose course of amiodarone and had aspiration pneumonia, sepsis, and hypotension followed the next day with ALT 981 U/L, AST 9380 U/L, CK 1096 U/L, Alk P 70 U/L, bilirubin 1.5 mg/dL, given N-acetylcysteine and recovered rapidly; unclear whether drug-induced or ischemic liver injury). 35446262
Lopes Dos Santos A, Lagarto M, Gouveia C. A rare case of intravenous amiodarone toxicity. Cureus. 2022;14:e27958. (70 year old Portuguese man with chronic heart failure and acute decompensation due to rapid atrial fibrillation, was treated with iv amiodarone and became confused 18 hours later with lactic acidosis and renal and liver dysfunction [bilirubin 4.8 mg/dL, ALT 5056 U/L, AST 10,310 U/L, normal Alk P and minimal increase in GGT, INR 2.8, creatinine 2.8] improving after stopping amiodarone). 36120239
Calderon-Martinez E, Landazuri-Navas S, Kaya G, Cinicola J. Chronic oral amiodarone as a cause of acute liver failure. J Med Cases. 2023;14:59-63. (84 year old woman with cardiomyopathy and atrial fibrillation on chronic low dose amiodarone was admitted for acute onset of lethargy, nausea, and diarrhea and was found to have acute liver failure [bilirubin 1.6 mg/dL, ALT 1589, Alk P 49, INR 2.7], amiodarone was stopped and she improved spontaneously, a pattern most resembling acute hepatic ischemia). 36896369
Samadi Takaldani AH, Negaresh M, Salimi M, Javanshir N. Amiodarone-induced blue man syndrome: a case report. J Med Case Rep. 2023;17:248. (51 year old white man with chronic heart failure and ventricular arrhythmias on amiodarone for 3 years developed grey-blue discoloration on nose and cheeks; no mention of liver test results and no follow up after amiodarone was stopped). 37291615
Tun MM, Pandey S, Adhikari S, Mainali A, Thapa A, Bisural R, Bista PB, et al. Amiodarone-induced liver attenuation on CT scan: alarming signal for toxicity and prompt discontinuation. Cureus. 2023;15:e39844. (77 year old woman with weight loss and fatigue and history of atrial fibrillation on amiodarone for 2 years [200 mg daily] had abnormal liver tests [ALT 161 rising to 450 U/L, but normal bilirubin, Alk P, INR and albumin] whereupon amiodarone was stopped, but symptoms were due to duodenal adenocarcinoma, and given palliative care “had an unfortunate demise a few months later”). 37397675
Nagata T, Takata K, Shakado S, Hirai F. Amiodarone-induced hepatotoxicity. BMJ Case Rep. 2023;16:e256679. (A 50-ish year old Japanese man with implantable cardioverter on oral amiodarone for 3 years developed fatigue and had abnormal liver tests [bilirubin 1.7, ALT 1601 U/L AST 861 U/L GGT 100 U/L, INR not given] with CT scan showing a bright liver; after amiodarone was stopped liver tests improved and CT scan 4 months later showed lessening of hyper density). 37914162
Murata N, Nishizawa T, Kim Y, Arioka H. Hepatic encephalopathy caused by long-term amiodarone use. Cureus. 2023;15:e50690. (72 year old Japanese woman with cardiomyopathy and ventricular tachyarrhythmias on oral amiodarone [200 mg daily] for 6 years developed hepatic encephalopathy [bilirubin 3.4 mg/dL, ALT 60 U/L, Alk P 104 U/L, albumin 2.6 g/dL, ammonia 246 μmoL, platelets 81,000/uL] with biopsy showing steatohepatitis [no mention of fibrosis] who improved once amiodarone was stopped but continued to have ammonia and bilirubin elevations during follow up). 38229783
Pop A, Halegoua-DeMarzio D, Barnhart H, Kleiner D, Avigan M, Gu J, Chalasani N, et al. Amiodarone and dronedarone cause liver injury with distinctly different clinical presentations. Dig Dis Sci. 2024;69:1479-1487. (In a U.S. prospective study of drug-induced liver injury conducted between 2004 and 2016, 3 cases of dronedarone vs 10 cases of amiodarone were identified and compared; dronedarone cases were on average younger [median age 58 vs 70 years], with a latency of 2 to 6 months vs longer, a hepatocellular pattern of injury vs mixed or cholestatic, and hepatitis-like histologic findings vs steatohepatitis with Mallory bodies and fibrosis or cirrhosis). 38416280
Al-Hiari M, Abumuhfouz M, Kayali L, Panta U, Rueda Rios C. A fatal consequence: amiodarone-induced multiorgan toxicity. Cureus. 2024;16:e62260. (70 year old man with atrial fibrillation treated with iv followed by oral amiodarone for several months developed multiorgan failure contributing factors being acute and chronic heart failure, shock, acute respiratory failure, infections, and multiple procedures and medications). 39006582
Yan J, Xu Y, Zhu Q. Case report: amiodarone-induced multi-organ toxicity. Front Cardiovasc Med. 2024;11:1401049. (73 year old Chinese woman was treated with oral amiodarone [200 mg daily] for two years when she was found to have abnormal liver tests [ALT 181 U/L, AST 270 U/L, bilirubin not provided] with CT scan showing liver hyper density; stopping therapy was followed by resolution of liver test abnormalities and decrease in hepatic hyper density). 39087074
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications estimated to be at a rate of 1:2,500 persons per year receiving amiodarone). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database between 2012 and 2022, none were attributed to amiodarone). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study between 2005 and 2019 included 8 cases [0.6%] attributed to amiodarone, occurring at an estimated rate of 1 per 4100 persons treated [95% confidence intervals 1:1,200 to 1:6,800]). 39317916
Kishimoto K, Tobita H, Kataoka M, Yazaki T, Oka A, Ishimura N, Tanabe K, et al. Changes in hepatic density due to oral amiodarone-induced liver injury shown by computed tomography. Intern Med. 2025;64:1828-1833. (74 year old woman taking oral amiodarone [200 mg daily] for 6 years developed fatigue and ascites [bilirubin 0.6 mg/dL, ALT 114 U/L, AST 120 U/L, albumin 3.1 g/dL, INR 2.6] with ascites, a dysmorphic and hyperdense liver, and splenomegaly, with subsequent progressive hepatic failure despite stopping amiodarone and death 10 weeks later). 39566986
Lerman TT, Gadot C, Greenberg N, Kruchin B, Rahat O, Buturlin K, Erez A, et al. The safety profile of amiodarone among older adults (age ≥75 years): a pharmacovigilance study from the FDA Data. Am J Med. 2025;138:819-826.. (Analysis of FDA’s Adverse Event Reporting System from 2003 to 2024 found 9196 reports, 4129 in older adults in whom bradycardia and interstitial lung disease were overrepresented whereas thyroid, liver and peripheral neuropathy were overrepresented regardless of age). 39842538
Bodirlau CI, Dumitru R, Dumitrescu C, Dumbrava M, Preda CM. Amiodarone-induced decompensated liver cirrhosis successfully managed with N-acetylcysteine and supportive therapy. J Gastrointestin Liver Dis. 2025;34:548-549.. (64 year old woman developed fatigue and ascites after taking oral amiodarone [200 mg twice daily] for 4.5 years with CT scan showing ascites and a dysmorphic and hyperdense liver while liver biopsy showed ballooning degeneration, Mallory bodies, inflammation and fibrosis, stopping amiodarone and N-acetylcysteine treatment was followed by clinical improvement). 41453096

## OTHER REFERENCE LINKS

1. Recent References on Amiodarone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=amiodarone/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222008/1/30%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Amiodarone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=amiodarone)